# Pantoprazole

## OVERVIEW

### Introduction

Pantoprazole is a proton pump inhibitor (PPI) and a potent inhibitor of gastric acidity which is widely used in the therapy of gastroesophageal reflux and peptic ulcer disease. Pantoprazole therapy is associated with a low rate of transient and asymptomatic serum aminotransferase elevations and is a rare cause of clinically apparent liver injury.

### Background

Pantoprazole, (pan toe' pra zole) like other PPIs, blocks gastric acid production by binding to and inactivating the H+/K+-ATPase of gastric parietal cells, causing inhibition of the proton pump that transports H+ into the gastric lumen, the final common step in gastric acid production. Pantoprazole is a prodrug and is converted to the active form in the acidic secretory canaliculi of parietal cells. Because the inhibition is irreversible, acid secretion is suppressed for 24 to 48 hours, until new proton pump molecules have been synthesized and transported to the cell membrane. Pantoprazole was the fourth PPI approved for use in the United States (2000) and now is in wide use. Pantoprazole is available as delayed release tablets of 20 and 40 mg, and in 40 mg vials for parenteral use generically and under the brand name of Protonix. The typical dose of pantoprazole for peptic ulcer disease is 40 mg once daily for 4 to 8 weeks with similar long term maintenance doses. Twice daily doses are recommended for more severe cases of gastrointestinal reflux and peptic ulcer disease, and doses of up to 240 mg daily for Zollinger-Ellison syndrome. Pantoprazole is very well tolerated. Side effects are uncommon and usually mild, and include diarrhea, nausea, vomiting, abdominal discomfort, flatulence, skin rash, headaches and dizziness. Severe adverse events are rare but can include hypersensitivity reactions. Long-term use may be associated with bone fractures, acute interstitial nephritis, lupus erythematosus, vitamin B12 deficiency and hypomagnesemia.

### Hepatotoxicity

Despite its wide use, pantoprazole has only rarely been associated with hepatic injury. In large scale, long term trials of pantoprazole, serum ALT elevations have occurred in less than 1% of patients and at rates similar to those that occur with placebo or comparator drugs. Only a small number of cases of clinically apparent liver disease attributed to pantoprazole have been published, but the clinical pattern of injury has resembled acute hepatic necrosis which has been described with other proton pump inhibitors. Clinically apparent liver injury due to proton pump inhibitors generally arises within the first 4 weeks of therapy and is characterized by an acute hepatocellular pattern of injury with rapid recovery upon withdrawal. Rash, fever and eosinophilia are rare, as is autoantibody formation. In large case series of drug induced liver injury, pantoprazole has accounted for few instances of symptomatic acute liver injury.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The acute onset and rapid recurrence of hepatic injury with proton pump inhibitors suggests a hypersensitivity reaction, but may merely reflect altered metabolism or acute toxicity of a metabolic byproduct. Pantoprazole is metabolized predominantly by hepatic CYP 2C19 with lesser metabolism by CYP 3A4. Drug interactions may occur with agents that share these pathways of metabolism.

### Outcome and Management

The mild and asymptomatic elevations in serum aminotransferase that have been observed during pantoprazole therapy are usually transient and may resolve even without dose modification. Clinically apparent liver injury due to pantoprazole is rare, but calls for prompt withdrawal of the agent. Cases of acute liver failure due to proton pump inhibitors have been described, but are exceedingly rare. There is no information about cross reactivity among the various PPIs after pantoprazole hepatotoxicity, but the PPIs all share a benzimidazole structure, and caution should be used in attempting to reintroduce another PPI after clinically apparent PPI associated hepatic injury.

Drug Class: Antiulcer Agents

Other Drugs in the Subclass, Proton Pump Inhibitors: Dexlansoprazole, Esomeprazole, Lansoprazole, Omeprazole, Rabeprazole

## CASE REPORT

### Case 1. Acute liver injury due to pantoprazole.

[Modified from: Cordes A, Vogt W, Maier KP. [Pantoprazole-induced hepatitis]. Dtsch Med Wochenschr 2003; 128: 611-4. German. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/12649798)]

A 46 year old woman with symptoms of gastroesophageal reflux developed epigastic pain 8 days after starting pantoprazole. She denied jaundice, dark urine, fever, rash or poor appetite. She had no history of liver disease, jaundice, alcohol abuse or risk factors for viral hepatitis. She took no other medications. Her serum aminotransferase levels had been normal 3 days previously when she underwent a routine upper endoscopy under midazolam anesthesia (which showed changes suggestive of gastroesophageal reflux disease). On examination, she had no fever, jaundice, rash, hepatomegaly or tenderness. Laboratory tests showed moderate elevations in serum aminotransferase levels and bilirubin of 1.0 mg/dL (Table). The alkaline phosphatase levels were normal, but lactic dehydrogenase was slightly elevated (LDH 686 U/L, normal <240). The white blood cell count was normal without eosinophilia. Tests for hepatitis A, B and C and for autoantibodies were negative. An ultrasound showed a gallstone without evidence of biliary obstruction. Pantoprazole was stopped. Serum bilirubin and ALT levels rose for a day and then began to fall and were near normal one week later. A liver biopsy was not done and she was not reexposed to pantoprazole or other proton pump inhibitors.

#### Key Points

Medication: | Pantoprazole (dose not given)
Pattern: | Hepatocellular (R=37)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 8 days to onset of symptoms, 9 days to jaundice
Recovery: | ~2 weeks
Other medications: | Intravenous midazolam, 3 days before onset

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
5 days | 0 | 12 | 13 | | Upper endoscopy
8 days | 0 | 359 | 175 | 1.0 | Epigastric pain
9 days | 1 day | 590 | 190 | 3.5 | Jaundice
10 days | 2 days | 555 | 180 | 2.5
12 days | 4 days | 310 | 170 | 0.6
17 days | 9 days | 100 | 100 | 0.5 | Discharged
Normal Values | | <17 | <130 | <1.2

* Values estimated from Figure 1.

#### Comment

This patient developed a mild hepatitis-like syndrome within 8-9 days of starting pantoprazole. The pattern of serum enzyme elevations was hepatocellular, but the LDH elevation suggested an acute hepatic necrosis-like clinical picture, which was further supported by the rapidity of improvement on stopping pantoprazole. Other possibilities were that the injury was due to midazolam anesthesia or to an undocumented episode of hypotension during the upper endoscopy, but both of those possibilities are unlikely. The signature pattern of short latency to onset of an acute hepatic necrosis with prompt improvement on stopping is typical of proton pump associated hepatotoxicity.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pantoprazole – Generic, Protonix®

DRUG CLASS

Antiulcer Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pantoprazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pantoprazole | 102625-70-7 | C16-H15-F2-N3-O4-S | Pantoprazole Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2019

Abbreviations: PPI, proton pump inhibitors

Zimmerman HJ. Proton pump inhibitors. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 720-1. (Expert review of hepatotoxicity published in 1999 states that aminotransferase elevations occur in ~1% of PPI treated patients and only 1 case of acute liver injury reported with omeprazole, none with the more recently released lansoprazole and pantoprazole).
Sharkey KA, McNaughton WK. Pharmacotherapy of gastric acidity, peptic ulcers, and gastroesophageal reflux disease. In, Brunton LL,Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 921-44. (Textbook of pharmacology and therapeutics).
Arnold R. Safety of proton pump inhibitors--an overview. Aliment Pharmacol Ther 1994; 8 Suppl 1: 65-70. (Side effects of PPIs are uncommon and no more frequent than with cimetidine and ranitidine; "Omeprazole had no clinically relevant effects on laboratory values including...liver function"). 8180297
Yusoff IF, Nairn P, Morgan CA. Multiple organ failure related to pantoprazole. Aust N Z J Med 1999; 9: 33-4. (68 year old with ulcer disease developed muscle aches, shortness of breath and abdominal pain 2 days after being switched from famotidine to pantoprazole [bilirubin 4.1 mg/dL, ALT 4080 U/L, Alk P 261 U/L, CPK 12,210 U/L, INR 3.1, lactate 7 mmol, creatinine 4.1 mg/dL], recovered within 2 weeks of stopping). 10677134
Reilly JP. Safety profile of the proton-pump inhibitors. Am J Health Syst Pharm 1999; 56 (23 Suppl 4): S11-7. (Review of side effects of proton pump inhibitors including long term tolerance). 10597119
Martin RM, Dunn NR, Freemantle S, Shakir S. The rates of common adverse events reported during treatment with proton pump inhibitors used in general practice in England: cohort studies. Br J Clin Pharmacol 2000; 50: 366-72. (Prescription event monitoring of common side effects of omeprazole, lansoprazole and pantoprazole from the UK found low rates of diarrhea [0.18-0.39/1000 days], abdominal pain [0.17-.21], nausea [0.16-0.22] and headache [0.10-0.17]; no analysis of liver toxicities). 11012560
Wilton LV, Key C, Shakir SA. The pharmacovigilance of pantoprazole: the results of postmarketing surveillance on 11 541 patients in England. Drug Saf 2003; 26: 121-32. (Prescription event monitoring among general practitioners in the UK during 6 months after launch of pantoprazole found low rate of adverse events, most common being diarrhea, nausea, headache and dizziness; among 12,521 forms returned, were 8 cases of jaundice and 2 of abnormal liver tests, but no details provided). 12534328
Cordes A, Vogt W, Maier KP. [Pantoprazole-induced hepatitis]. Dtsch Med Wochenschr 2003; 128: 611-4. German. (46 year old developed abdominal pain 8 days after starting pantoprazole [bilirubin <1.0 mg/dL, ALT 359 U/L, Alk P normal], resolving within 12 days of stopping: Case 1). 12649798
Wellhöfer B. [Pantoprazole-induced hepatitis]. Dtsch Med Wochenschr 2003; 128: 1502; author reply 1502. German. (Letter in response to Cordes [2003] suggesting that the hepatic injury may have been due to cholelithiasis and would have warranted endoscopic retrograde pancreatocholangiography). 12840780
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to an H2 blocker or proton pump inhibitor). 15390328
de Abajo FJ, Montero D, Madurga M, García Rodríguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. (Analysis of General Practice Research Database from UK on 1.6 million persons from 1994-2000 found 128 cases of drug induced liver injury [2.4/100,000 person years]; 3 cases were attributed to cimetidine for an odds ratio of 2.0 compared to controls [n=5000] which was not statistically significant). 15206996
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002: 103 cases identified as highly probable, probable or possible, one case attributed to ranitidine and one to omeprazole, but none to the other antiulcer agents). 16165719
Darabi K. Proton-pump-inhibitor-induced hepatitis. South Med J 2005; 98: 844-5. (39 year old developed fatigue and abdominal pain 2 weeks after starting pantoprazole [bilirubin 1.2 mg/dL, ALT 3061 U/L, Alk P 89 U/L], which gradually resolved after drug was stopped). 16144190
Salgueiro E, Rubio T, Hidalgo A, Manso G. Safety profile of proton pump inhibitors according to the spontaneous reports of suspected adverse reactions. Int J Clin Pharmacol Ther 2006; 44: 548-56. (Analysis of PPI related reports to Spanish Pharmacovigilance Database during 2004 found 58 reports of liver injury from omeprazole [n=36], lansoprazole [7], pantoprazole [12], rabeprazole [2] and esomeprazole [1], correlating somewhat with relative number of prescriptions; 82% were taking other medications; most "evolved to recovery"). 17176621
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Population based survey of 126 cases of acute liver injury due to drugs between 1993-1999 in Spain; 8 were attributed to ranitidine alone [incidence 5.1/100,000 person-years] and 5 to omeprazole alone [2.1/100,000], no mention of pantoprazole). 17539979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 2 were attributed to ranitidine, none to cimetidine or the proton pump inhibitors). 18955056
Sandig C, Flechtenmacher C, Stremmel W, Eisenbach C. Pantoprazole induces severe acute hepatitis. Z Gastroenterol 2011; 49: 207-10. (52 year old woman developed jaundice 1 month after starting pantoprazole [bilirubin 4.8 mg/dL, ALT 1276 U/L, Alk P 196 U/L], resolving within 2 months of stopping). 21298607
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (World wide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, no antiulcer medication was listed in the top 40 causes). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to pantoprazole or other antiulcer medications). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to rabeprazole, despite it being among the 10 most prescribed medications in Iceland). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to rabeprazole or other proton pump inhibitors). 24552865
Aslan M, Celik Y, Karadas S, Olmez S, Cifci A. Liver hepatotoxicity associated with pantoprazole: a rare case report. Wien Klin Wochenschr 2014; 126 (11-12): 390-2. (35 year old man developed nausea and fatigue 2 months after starting pantoprazole [bilirubin 0.8 mg/dL, ALT 1541 U/L, Alk P 359 U/L], resolving within a few weeks of stopping). 24652021
van der Schaft J, van Schaik RH, van den Broek MP, Bruijnzeel-Koomen CA, de Bruin-Weller MS. Increased liver enzyme levels during azathioprine treatment: beware of concomitant use of proton pump inhibitors. Br J Dermatol 2015; 173: 1338-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/26139089) (Three patients with atopic dermatitis treated with azathioprine [150 mg daily] developed ALT elevations 2-5 weeks after starting pantoprazole or omeprazole [ALT 14 to 25 U/L before rising to 42 to 254 U/L after], resolving within 1-6 months after stopping the proton pump inhibitor and despite continuation of azathioprine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 3 [0.3%] were attributed to proton pump inhibitors, including 1 each from omeprazole, esomeprazole and lansoprazole, but none from pantoprazole or rabeprazole). 25754159
Tsai CF, Chen MH, Wang YP, Chu CJ, Huang YH, Lin HC, Hou MC, Let al. Proton pump inhibitors increase risk for hepatic encephalopathy in patients With cirrhosis in a population study. Gastroenterology 2017; 152: 134-41. (Analysis of the Taiwan National Health Insurance database found a higher rate of PPI use among patients with cirrhosis who developed hepatic encephalopathy [38%: 445 of 1166] compared to a matched group with cirrhosis who did not [rate not provided]; the relative risk was raised for all agents except for rabeprazole). 27639806
Weersink RA, Bouma M, Burger DM, Drenth JPH, Froukje Harkes-Idzinga S, Hunfeld NGM, Metselaar HJ, et al. Safe use of proton pump inhibitors in patients with cirrhosis. Br J Clin Pharmacol 2018; 84: 1806-20. (Systematic review of 69 publications in the literature suggested plasma levels of pantoprazole are more than 7-fold elevated in patients with cirrhosis and that patients with Child Pugh Class A or B should receive omeprazole and only esomeprazole be used in Child Pugh Class C cirrhosis). 29688583
Meunier L, Ursic-Bedoya J, Pageaux GP, Larrey D. Pantoprazole-induced autoimmune chronic hepatitis. Liver Int 2018; 38: 995-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/29532602) (52 year old woman developed jaundice 8 weeks after starting pantoprazole [bilirubin 10.4 mg/dL, ALT 1520 U/L, Alk P 395 U/L, ANA 1:160], improving but not resolving completely after stopping pantoprazole, ultimately responding to budesonide therapy that was discontinued 2 years later without subsequent relapse but while still on ursodiol).

## OTHER REFERENCE LINKS

1. Recent References on Pantoprazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Pantoprazole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Pantoprazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pantoprazole)